# Horsetail

## OVERVIEW

### Introduction

Horsetail is an extract of the plant Equisetum arvense which has been used in traditional medicine for bladder and kidney conditions and to promote wound healing. Oral forms of horsetail have been implicated in instances of serum aminotransferase elevations, but it has not been convincingly linked to instances of clinically apparent liver injury with jaundice.

### Background

Horsetail is derived from fresh or dried, green shoots of the plant Equisetum arvense, a fern-like, non-flowering weed found in low lying wetland areas in North America, Europe, the Middle East, and Asia. Extracts contain multiple flavonoids, flavone glycosides, caffeic acid ester, silicic acid and pyridine alkaloids. In animal models, horsetail has been shown to have diuretic and antispasmodic activities, and it has been used in traditional medicine for centuries for edema, bladder and renal conditions and to promote healing of wounds and burns. More recently, horsetail has been purported to have beneficial effects on arthritis, osteoporosis, asthma, chronic fatigue, dyspepsia, constipation, aging, well-being and various skin ailments. The bases of these claims have not been substantiated in controlled trials in humans, but laboratory studies suggest that components of horsetail have antioxidant, antiinflammatory and hepato-protective properties. Horsetail is found in multiple commercial forms, the recommended daily dose ranging widely to as high as several grams daily. Horsetail is generally well tolerated without adverse events; minor side effects may include diarrhea, abdominal discomfort and nausea. Rare instances of hypersensitivity reactions, skin rash and allergic dermatitis have been described.

### Hepatotoxicity

In several small, rather short term clinical trials, horsetail in conventional oral doses (up to 6 grams daily) was typically described as having no adverse side effects, with no mention of either hepatotoxicity or ALT elevations. Isolated reports of serum enzyme elevations during horsetail therapy have been reported from large national registries, but usually without details of the timing, duration and severity of the abnormalities. Single case reports of liver injury with jaundice attributed to horsetail have appeared, but other possible diagnoses were not adequately excluded (Case 1). Thus, there is little evidence that horsetail in conventional oral doses or as herbal tea causes clinically apparent liver injury with jaundice in humans, but it has been implicated in rare instances of transient serum aminotransferase elevations without jaundice. Use of high doses given long term in persons with preexisting liver disease or cirrhosis is discouraged.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which horsetail might cause liver injury is unknown. The typical daily dose is quite high (several grams) and the possibility of contamination or mislabeling of other species of Equisetum (such as E. palustre or marsh horsetail, E. hyenale or rough horsetail, and E. sylvaticum or wood horsetail) are possible reasons for occasional liver injury associated with its use.

### Outcome and Management

Hepatotoxicity from horsetail is rare and generally mild; cases have been self-limiting upon stopping the herbal.

Drug Class: Herbal and Dietary Supplements

Other names: Field Horsetail, Bottle-Brush, Dutch Rushes, Horse Willow, Pewter Wort and Toadpipe

## CASE REPORT

### Case 1. Acute hepatocellular jaundice attributed to horsetail.(1)

A 52 year old man developed jaundice 15 days after starting an herbal juice prepared from Equisetum arvense (horsetail) as phytotherapy of renal colic. During evaluation for renal colic before starting the herbal drink, he was found to have abnormal liver tests (ALT 150 U/L, AST 141 U/L, bilirubin 1.6 mg/dL) but the cause was not identified. He did not drink alcohol and had no risk factors or known history of liver disease. However, within two weeks of starting the herbal drink he developed jaundice, dark urine and itching. On presentation he was markedly jaundiced with a total bilirubin of 18.2 mg/dL and direct of 13.3 mg/dL, ALT 1117 U/L, AST 815 U/L and alkaline phosphatase 298 U/L. The prothrombin time was elevated at 17.1 seconds, the platelet count reduced at 120,000/µL, and serum albumin low at 3.0 g/dL. Tests for viral hepatitis revealed that he was positive for HBsAg, negative for HBeAg but with high levels of HBV DNA (3.5 million IU/mL). He tested positive for anti-HBc, but was negative for IgM anti-HBc. Tests for hepatitis A, C and D were negative as were autoantibodies (ANA and SMA). Imaging showed a normal appearing liver but prominent splenomegaly (17 cm by ultrasound). A liver biopsy was not done. His liver tests improved with stopping therapy (Table) and 8 weeks later were close to baseline levels but still distinctly elevated with an ALT of 166 U/L, AST 177 U/L, and bilirubin 2.7 mg/dL.

#### Key Points

Medication: | Equisetum arvense juice [900 mL] daily for 2 weeks
Pattern: | Hepatocellular [R=20]
Severity: | 4+ (jaundice, hospitalization, abnormal protime)
Latency: | 2 weeks
Recovery: | ~8 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Protime (sec) | Other
Pre | Pre | 150 | 171 | 1.6 | 12.6 | Routine tests before starting
2 weeks | 0 | 1117 | 298 | 18.2 | 17.1 | Admission, Horsetail stopped
3 weeks | 1 week | 375 | | 14.4 | 15.1
4 weeks | 2 weeks | 197 | | 4.8 | 15.0
10 weeks | 8 weeks | 177 | | 2.6 | 13.9
Normal Values | | <50 | <270 | <1.2 | <14.5

#### Comment

This was the first and the only published report of clinically apparent liver injury attributed to horsetail (Equisetum arvense). However, the history and course were also compatible with a spontaneous flare of chronic hepatitis B. The presence of splenomegaly and thrombocytopenia as well as the “reversal” of the ALT to AST ratio suggests the presence of cirrhosis, undoubtedly made worse by this transient flare of disease. Further follow up was not provided. Based upon this case report, the use of high doses of horsetail is not recommended for patients with underlying liver disease.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Horsetail – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/843.html#Safety)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Horsetail | 129677-90-3 | Herbal | Not Applicable

## CITED REFERENCE

1 Kilinçalp S, Ekiz F, Başar Ö, Coban S, Yüksel O. (2012). Equisetum arvense (field horsetail)-induced liver injury. Eur J Gastroenterol Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2022

Abbreviations: EAE, Equisetum arvense extract; HCTZ, hydrochlorothiazide; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not horsetail).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of horsetail).
Horsetail. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 458-9. (Compilation of short monographs on herbal medications and dietary supplements).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were attributed to herbal products, including Ma huang, usnic acid, kava, chaparral and skullcap; but none attributed to horsetail).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 6 attributed to horsetail, including 2 cases with ALT elevations; no details given).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not horsetail).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; horsetail is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention horsetail).
Kilinçalp S, Ekiz F, Başar Ö, Coban S, Yüksel O. (2012). Equisetum arvense (field horsetail)-induced liver injury. Eur J Gastroenterol Hepatol. (52 year old man developed jaundice 15 days after starting Equisetum arvense juice [500 mL daily] for renal colic [bilirubin 18.2 mg/dL, ALT 181 U/L, Alk P 298 U/L, Protime 17.1 sec, HBsAg positive, HBV DNA 3.6 million IU/mL], which improved after stopping the herbal, but the diagnosis could also have been a spontaneous flare of a previously unsuspected chronic hepatitis B: Case 1).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing horsetail).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention horsetail).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to horsetail).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, but does not include mention of horsetail).
Carneiro DM, Freire RC, Honório TC, Zoghaib I, Cardoso FF, Tresvenzol LM, de Paula JR, et al. (2014). Randomized, double-blind clinical trial to assess the acute diuretic effect of Equisetum arvense (Field horsetail) in healthy volunteers. Evid Based Complement Alternat Med. (Among 36 healthy male volunteers who received serial 4-day courses of Equisetum arvense extract [EAE: 900 mg], hydrochlorothiazide [HCTZ: 25 mg] or placebo, both EAE and HCTZ produced a diuresis and averse events were uncommon; no mention of ALT levels or hepatotoxicity).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss horsetail specifically).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss horsetail).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while one anicteric, self-limited hepatocellular case was scored as probably due to horsetail).
Popovych V, Koshel I, Malofiichuk A, Pyletska L, Semeniuk A, Filippova O, Orlovska R. (2019). A randomized, open-label, multicenter, comparative study of therapeutic efficacy, safety and tolerability of BNO 1030 extract, containing marshmallow root, chamomile flowers, horsetail herb, walnut leaves, yarrow herb, oak bark, dandelion herb in the treatment of acute non-bacterial tonsillitis in children aged 6 to 18 years. Am J Otolaryngol. (Among 224 children ages 6 to 18 years with non-bacterial tonsilitis treated with a commercially available herbal solution called “Tonsilgon” which consisted of extracts from 7 herbs including horsetail [Herba equiseti] for 10 days or given conventional therapy, symptoms improved more rapidly with the herbal mixture and “no adverse events were registered”).
Greca RD, Cunha-Silva M, Costa LBE, Costa JGF, Mazo DFC, Sevá-Pereira T, Nascimento MMC, et al. (2020). Vanishing bile duct syndrome related to DILI and Hodgkin lymphoma overlap: A rare and severe case. Ann Hepatol. (25 year old woman developed pruritus and jaundice 45 days after starting a regimen of multiple agents for weight loss including horsetail, garcinia, bupropion, sertraline, metformin and orlistat [bilirubin 19.6 mg/dL, ALT 199 U/L, Alk P 1395 U/L, INR 1.34], with only modest improvement on stopping and subsequent liver biopsy showing vanishing bile duct syndrome and further evaluation demonstrating Hodgkin disease).
Schloss J, Ryan K, Steel A. (2021). A randomised, double-blind, placebo-controlled clinical trial found that a novel herbal formula Urox® (Bedtime Buddy®) assisted children for the treatment of nocturnal enuresis. Phytomedicine. (Among 48 children with enuresis treated with “Urox Junior” [a commercial mixture of Crataeva nurvala, Lindera aggregate and horsetail] or placebo for 8 weeks, the mean number of nights with bed wetting decreased more with the herbal product [5.8 to 4.6 per week] than placebo [4.4 to 3.8 per week] and there were no adverse events attributable to the product but ALT levels were not monitored).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while horsetail was listed as a concomitantly taken herb in 2 cases).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; horsetail was implicated in 7 cases but details were not provided).
Carneiro DM, Jardim TV, Araújo YCL, Arantes AC, de Sousa AC, Barroso WKS, Sousa ALL, et al. (2022). Antihypertensive effect of Equisetum arvense L.: a double-blind, randomized efficacy and safety clinical trial. Phytomedicine. (Among 58 adults with hypertension treated with Equisetum arvense [900 mg] or hydrochlorothiazide [25 mg] daily for 3 months, both systolic and diastolic blood pressure declined to a similar extent in both groups, adverse events were uncommon [3.6% vs 4.7% ) and there were no signs of liver toxicity).

## OTHER REFERENCE LINKS

1 Recent References on Horsetail: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Horsetail+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Horsetail: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Horsetail)